# Labetalol

## OVERVIEW

### Introduction

Labetalol is an antihypertensive agent with both alpha- and beta-adrenergic receptor blocking activity. Labetalol has been linked to several cases of clinically apparent drug induced liver disease, some of which have been severe and even fatal.

### Background

Labetalol (la bayt' a lol) is a unique antihypertensive agent that has both alpha- and beta-adrenergic receptor blocking activity. The beta-blockade is nonselective, acting on both beta-1 and beta-2 adrenergic receptors. Beta-1 adrenergic blockade reduces the heart rate and myocardial contractility by slowing the AV conduction and suppressing automaticity. Beta-2 blockade affects peripheral vascular resistance and can cause bronchospasm and hypoglycemia. The alpha blockade is largely directed at the alpha-1 receptors and leads to relaxation of arterial smooth muscle and vasodilation. Labetalol was approved for use in the United States in 1984 and currently more than 2 million prescriptions are filled yearly. Current indications for labetalol are in the therapy of hypertension alone or in combination with other agents. Parenteral forms of labetalol are indicated for therapy of hypertensive emergencies, severe hypertension and pheochromocytoma. Labetalol is available in tablets of 100, 200 and 300 mg in generic formulations and under the trade name Trandate. Parenteral formulations for intravenous administration are also available. The typical oral dose of labetalol in adults is 100 mg twice daily initially with subsequent dose adjustments based upon clinical response and tolerance to a range of 200 to 1200 mg daily. Common side effects include bradycardia, hypotension, fatigue, dizziness, orthostatic hypotension, depression, memory loss, impotence, weight gain and diarrhea. As with all beta-blockers, sudden withdrawal can trigger rebound hypertension.

### Hepatotoxicity

Labetalol therapy has been associated with mild-to-moderate elevations of serum aminotransferase levels in up to 8% of patients, a rate far higher than with other beta-blockers. These elevations, however, are usually transient, not associated with symptoms, and can resolve even with continuation of therapy. Idiosyncratic, clinically apparent liver injury from labetalol is rare, but several instances have been reported as isolated case reports as well as in case series. The liver injury typically arises after 4 to 16 weeks of therapy and the pattern of serum enzyme elevations is usually hepatocellular with an acute hepatitis-like onset and course. Immunoallergic features (rash, fever, eosinophilia) are uncommon as is autoantibody formation. While most cases resolve rapidly once labetalol is stopped, there have been several instances of acute liver failure and death or need for emergency liver transplantation associated with labetalol use, particularly if there is a delay in its discontinuation. Labetalol is the beta-blocker with the highest apparent risk for causing clinically apparent liver injury.

Likelihood score: C (probable although rare cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism of labetalol hepatic injury is unknown, but it believed to be due to metabolic idiosyncratic disposition of the agent, which is known to be extensively metabolized in the liver. There is little evidence for hypersensitivity as the cause of injury but it is likely to be due to an idiosyncractic rather than an intrinsic reaction.

### Outcome and Management

Severity ranges from minimal and transient ALT elevations to clinically apparent acute hepatitis with jaundice to acute liver failure and death or need for liver transplantation. No instances of chronic hepatic injury or vanishing bile duct syndrome attributable to labetalol have been reported. Rechallenge is usually followed by recurrence of liver injury and should be avoided. There is little information on whether there is cross reactivity of the liver injury with other beta-blockers and patients who are switched to other agents should be carefully monitored.

References to the safety and potential hepatotoxicity of labetalol are provided in the overview on Beta-Adrenergic Receptor Antagonists, last updated June 2019.

Drug Class: Beta-Adrenergic Receptor Antagonists

## CASE REPORT

### Case 1. Labetalol induced acute liver injury.

[Modified from: Douglas DD, Yang RD, Jensen P, Thiele DL. Fatal labetalol-induced hepatic injury. Am J Med 1989; 87: 235-6. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/2757062)]

A 63 year old woman developed nausea and dark urine approximately 3 months after starting labetalol (200 mg daily) for hypertension. She had no previous history of liver disease, jaundice, or risk factors for viral hepatitis. She was not taking any other medications and denied alcohol abuse. Laboratory testing showed serum bilirubin of 3.6 mg/dL and serum enzyme elevations typical of acute hepatitis (Table). She was negative for serological markers for hepatitis A and B. No diagnosis was made, and she was given another prescription for labetalol, but evidently stopped taking it on her own. Over the next few weeks she recovered, but was then lost to follow up for at least 6 months. When seen again, she had normal liver tests and was hypertensive. Labetalol was restarted. Two months later she developed anorexia and the following month presented with jaundice and serum bilirubin of 3.1 mg/dL. Labetalol was stopped and she was monitored closely. Tests for viral hepatitis were again negative as were routine autoantibodies. Abdominal ultrasound showed gallstones, but no evidence of biliary obstruction. There was mild ascites. Her liver condition worsened, and she developed progressive hepatic failure and died approximately 6 weeks after stopping labetalol for the second time. Autopsy showed a shrunken liver with extensive multilobular collapse with broad bands of fibrosis.

#### Key Points

Medication: | Labetalol (200 mg daily)
Pattern: | Hepatocellular (R=23)
Severity: | 2+ (initially); 5+ (upon reexposure); fatal
Latency: | 3 months
Recovery: | 1 month after initial episode
Other medications: | None

#### Laboratory Values

Weeks After Starting | Weeks After Stopping | AST* (U/L) | Alk P* (U/L) | Bilirubin* (mg/dL) | Other
0 (pre) | 0 | 11 | 92 | 0.3
12 | 0 | 1253 | 205 | 3.6 | Labetolol stopped
14 | 2 weeks | 247 | 150 | 1.5
16 | 4 weeks | 37 | 111 | 0.4
Patient was lost to follow up for 6 months
0 | 0 | 13 | 117 | 0.3 | Labetalol restarted
13 | 0 | 1007 | 172 | 3.1
16 | 3 | 582 | 283 | 9.5
17 | 4 | 402 | 315 | 11.3
18 | 5 | 303 | 321 | 12.0
19 | 6 | 225 | 266 | 16.8 | Death from liver failure
Normal Values | | <40 | <110 | <1.2

* Converted from μKat/L and μmol/L.

#### Comment

This patient developed an acute hepatitis-like clinical picture 3 months after starting labetalol. Despite the lack of a suitable diagnosis, labetalol was not discontinued, although the patient evidently stopped taking it on her own and did not return for further management of her hypertension. When seen 6 months later, labetalol was restarted and a similar clinical syndrome arose 2 to 3 months later, but with a progressive and ultimately fatal course. Labetalol has been implicated in at least a dozen cases of acute liver injury with a predominantly hepatocellular pattern of enzyme elevations, a latency period of 2 to 16 weeks, and fatal outcome or emergency liver transplantation in several instances. In contrast, most cases of clinically apparent liver injury due to other beta-blockers have had a somewhat shorter latency period (2 to 12 weeks) and a milder course and outcome. Acute liver injury has also been described with dilevolol, which is one of the 4 stereoisomers of labetalol that has predominantly beta-adrenergic blocking activity.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Labetalol – Generic, Trandate®

DRUG CLASS

Beta-Adrenergic Receptor Antagonists

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=labetalol)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Labetalol | 36894-69-6 | C19-H24-N2-O3 | Labetalol Chemical Structure

## OTHER REFERENCE LINKS

1. Recent References on Labetalol: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Labetalol/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Labetalol: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Labetalol)